# Daptomycin

## OVERVIEW

### Introduction

Daptomycin is an intravenously administered, broad spectrum antibiotic used to treat complex skin and tissue infections, endocarditis and bacteremia. Daptomycin is associated with a low to modest rate of serum enzyme elevations during therapy, but is a very rare cause of clinically apparent liver injury.

### Background

Daptomycin (dap" toe mye' sin) is a cyclic lipopeptide antibiotic that is poorly absorbed orally and must be given intravenously. Daptomycin appears to act by binding to bacterial membranes causing their depolarization and disruption and cell death. Daptomycin has been shown to be highly effective in treating severe gram-positive bacterial infections, including methicillin resistant Staphylococcal aureus (MRSA) and vancomycin resistant enterococcal (VRE) infections, and bacterial resistance is rare. Because of its value in treating multidrug resistant infections, daptomycin is usually limited for use in complicated infections in the hospital setting. Daptomycin was approved for use in 2006 and current indications include complicated skin and skin structure infections and severe bacteremia and endocarditis caused by susceptible organisms. Daptomycin is available in generic forms and under the brand name Cubicin in single use vials of 500 mg. The typical dose is 4 to 6 mg/kg once daily for 7 to 28 days, depending upon the type of infection and organism. Side effects may include restlessness, dizziness, headache, fever, abdominal pain, nausea, diarrhea and cough. Serum creatine kinase (CK) levels are often raised during intravenous daptomycin therapy, and many instances symptomatic myositis and of rhabdomyolysis have been reported, particularly with higher doses of therapy and in patients on concurrent statin medications. Rare complications include hypersensitivity reactions and interstitial pneumonitis.

### Hepatotoxicity

Elevations in serum aminotransferase levels occur in 2% to 6% of patients receiving daptomycin, rates that are minimally higher than with placebo or comparator drugs. The elevations are generally mild-to-moderate, asymptomatic and self-limited, frequently resolving without discontinuation or even interruption of therapy. Isolated case reports of possible liver injury from daptomycin have been reported, but serum bilirubin was normal in most cases, and the serum aminotransferase elevations were mild-to-moderate and typically accompanied by severe muscle injury with marked CK elevations. Such cases without jaundice or alkaline phosphatase elevations are more likely due to muscle rather than liver injury. Nevertheless, a few case reports of mild jaundice with a hepatocellular pattern of serum enzyme elevations and normal CK levels has been published. The latency to onset was 5 weeks, immunoallergic and autoimmune features were not present, and resolution was slow with mild abnormalities still present 6 weeks later. Thus, clinically apparent liver injury from daptomycin probably occurs, but is quite rare.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Liver Injury

The mild-to-moderate serum aminotransferase elevations that occur during daptomycin therapy may represent muscle rather than liver injury and are likely due to direct toxicity to muscle. The rare instances of jaundice and hepatitis with daptomycin therapy probably represent idiosyncratic liver injury.

### Outcome and Management

The severity of the liver injury linked to daptomycin therapy is usually mild and self-limited, and dose modification or discontinuation is rarely necessary. No instances of acute liver failure, chronic hepatitis or vanishing bile duct syndrome have been attributed to daptomycin therapy. The outcome of reexposure to daptomycin after liver or muscle injury has not been reported. Also, there is no information on cross sensitivity between daptomycin and other peptide antibiotics (such as the glycopeptides antibiotics, vancomycin and teicoplanin), but there is little reason to believe that such sensitivity exists.

Drug Class: Antiinfective Agents

## CASE REPORT

### Case 1. Mild liver injury arising during daptomycin therapy.

[Modified from: Abraham G, Finkelberg D, Spooner LM. Daptomycin-induced acute renal and hepatic toxicity without rhabdomyolysis. Ann Pharmacother 2008; 42: 719-21. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/18381844)]

A 35 year old man with paraplegia and a decubitus ulcer with a methicillin resistant Staphylococcus aureus infection as well as a urinary tract infection with vancomycin resistant enterococci was treated at home with intravenous daptomycin in a dose of 4 mg/kg once daily. After 5 weeks of this treatment, he developed nausea and fatigue and was found to have abnormal liver tests. He had no history of liver disease and denied alcohol abuse and exposures to viral hepatitis. He had a history of drug allergy to penicillin (rash). Other medications included clonazepam for sleep, sertraline for depression, hydromorphone for pain, prochlorperazine for nausea, ferrous sulfate and vitamin C, all of which he had taken for more than a year. On examination, he was anicteric, afebrile and without findings indicative of acute or chronic liver disease. Laboratory tests showed bilirubin 2.0 mg/dL, ALT 8050 U/L, AST 6020 U/L, alkaline phosphatase 370 U/L, INR 1.2 and CK 111 U/L. Daptomycin was stopped and vancomycin and ciprofloxacin were begun. Tests for hepatitis A, B and C were negative and computed tomography of the abdomen showed no biliary dilatation or hepatic masses. Blood cultures grew Stenotrophomonas maltophilia which was sensitive to ciprofloxacin. Vancomycin was discontinued and he remained afebrile. Liver tests improved slowly and were near-normal six weeks later (Table).

#### Key Points

Medication: | Daptomycin (325 mg daily)
Pattern: | Hepatocellular (R=33)
Severity: | 3+ (bilirubin elevation and hospitalization)
Latency: | 5 weeks
Recovery: | Almost complete at 6 weeks
Other medications: | Clonazepam, sertraline, hydromorphone, prochlorperazine, ferrous sulfate, vitamin C

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
2 weeks | Pre | 20
5 weeks | 0 | 8050 | 370 | 2.0 | Admission
6 weeks | 1 week | 819 | | | Discharge
12 weeks | 7 weeks | 81 | | | AST 51
Normal Values | | <40 | <130 | <1.2

#### Comment

The height of the serum aminotransferase levels and rapid fall with stopping daptomycin suggests a direct hepatic toxicity; the phenotype of acute hepatic necrosis. This pattern can also occur after an acute ischemic injury to the liver or acetaminophen (or cocaine) overdose. None of these possibilities seemed reasonable in this case report.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Daptomycin – Generic, Cubicin®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Daptomycin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Daptomycin | 103060-53-3 | C72-H101-N17-O26 | Chemical structure for Daptomycin

## ANNOTATED BIBLIOGRAPHY

References updated: 04 December 2017

Abbreviations: MRSA, methicillin resistant Staphylococcus aureus

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity published in 1999, does not discuss daptomycin).
Moseley RH. Daptomycin. Hepatotoxicity of antimicrobial and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 470. (Expert review of antibiotic induced liver injury, mentions rare reports of asymptomatic serum enzyme elevations in patients receiving daptomycin).
MacDougall C, Chambers HF. Daptomycin. Protein synthesis inhibitors and miscellaneous antibacterial agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1542-3. (Textbook of pharmacology and therapeutics; daptomycin is a cyclic lipopeptide antibiotic that was discovered 25 years ago, but developed clinically more recently because of the growing need for antibiotics effective against multidrug resistant bacteria).
Veligandla SR, Louie KR, Malesker MA, Smith PW. Muscle pain associated with daptomycin. Ann Pharmacother 2004; 38: 1860-2. (26 year old woman with lupus erythematosis developed muscle pains 7 days after starting daptomycin for MRSA bacteremia [CK rising from 7 to 492 U/L], resolving within 3 days of stopping daptomycin). 15367725
Papadopoulos S, Ball AM, Liewer SE, Martin CA, Winstead PS, Murphy BS. Rhabdomyolysis during therapy with daptomycin. Clin Infect Dis 2006; 42: e108-10. (45 year old woman with refractory leukemia on chemotherapy developed rhabdomyolysis 9 days after starting daptomycin therapy for a vancomycin resistant enterococcal infection [CK 108 rising to 5350 U/L, urine myoglobin 47,166 ng/mL], with multiorgan failure and death 10 days after stopping daptomycin). 16705566
Echevarria K, Datta P, Cadena J, Lewis JS 2nd. Severe myopathy and possible hepatotoxicity related to daptomycin. J Antimicrob Chemother 2005; 55: 599-600. (52 year old man with hepatitis C and osteomyelitis developed rash on vancomycin, was switched to daptomycin and 9 days later developed muscle weakness [CK 20,771 U/L, ALT 48 U/L, AST 239 U/L, Alk P 118 U/L] without jaundice, enzymes falling to normal within 2 weeks of stopping). 15743894
Kazory A, Dibadj K, Weiner ID. Rhabdomyolysis and acute renal failure in a patient treated with daptomycin. J Antimicrob Chemother 2006; 57: 578-9. (53 year old woman with osteomyelitis developed muscle weakness 10 days after starting intravenous daptomycin [CK 21,243 U/L, ALT 219 U/L, AST 375 U/L, bilirubin and Alk P not given], with resolution on stopping). 16410267
Fowler VG Jr, Boucher HW, Corey GR, Abrutyn E, Karchmer AW, Rupp ME, Levine DP, et al.; S. aureus Endocarditis and Bacteremia Study Group. Daptomycin versus standard therapy for bacteremia and endocarditis caused by Staphylococcus aureus. N Engl J Med 2006; 355: 653-65. (In a controlled trial of daptomycin vs standard antibiotic therapy in 135 patients with Staphylococcus aureus bacteremia, CK elevations above 500 U/L were more frequent with daptomycin [9.5% vs 1.5%], while renal dysfunction was less frequent [11% vs 26%]; no mention of hepatotoxicity or ALT elevations). 16914701
Patel SJ, Samo TC, Suki WN. Early-onset rhabdomyolysis related to daptomycin use. Int J Antimicrob Agents 2007; 30: 472-4. (68 year old woman with renal insufficiency, polymyalgia rheumatica, recurrent cholangitis and enterococcal sepsis developed severe muscle weakness and pain 4 days after starting daptomycin [CK 25,234 U/L, ALT 332 U/L, AST 1155 U/L], resolving within 10 days of stopping). 17804204
Abraham G, Finkelberg D, Spooner LM. Daptomycin-induced acute renal and hepatic toxicity without rhabdomyolysis. Ann Pharmacother 2008; 42: 719-21. (35 year old man developed fatigue and nausea 5 weeks after starting intravenous daptomycin for osteomyelitis [bilirubin 2.0 mg/dL, ALT 6020 U/L, Alk P 370 U/L, CK 111 U/L, creatinine 2.9 mg/dL, INR 1.2], with almost complete resolution 6 weeks after switching to vancomycin: Case 1). 18381844
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network(DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none were attributed to daptomycin). 19132805
Odero RO, Cleveland KO, Gelfand MS. Rhabdomyolysis and acute renal failure associated with the co-administration of daptomycin and an HMG-CoA reductase inhibitor. J Antimicrob Chemother 2009; 63: 1299-300. (A patient of undisclosed age and gender on simvastatin [80 mg daily] developed muscle pains and weakness 16 days after starting daptomycin for suspected septicemia [CK 8995 U/L and renal insufficiency], resolving within 7 days of stopping). 19346518
Crompton JA, North DS, McConnell SA, Lamp KC. Safety and efficacy of daptomycin in the treatment of osteomyelitis: results from the CORE Registry. J Chemother 2009; 21: 414-20. (Among 327 patients treated with daptomycin for 1 to 210 days for osteomyelitis, CK elevations occurred in 7% of patients, but only 2 had rhabdomyolysis and another patient had "liver function test abnormalities", but no details given). 19622460
Figueroa DA, Mangini E, Amodio-Groton M, Vardianos B, Melchert A, Fana C, Wehbeh W, et al. Safety of high-dose intravenous daptomycin treatment: three-year cumulative experience in a clinical program. Clin Infect Dis 2009; 49: 177-80. (Among 61 patients with complicated infections treated with daptomycin, only 3 had symptomatic CK elevations [above 1000 U/L], all of which resolved with stopping; no mention of ALT elevations or hepatotoxicity). 19500039
Kullar R, Davis SL, Levine DP, Zhao JJ, Crank CW, Segreti J, Sakoulas G, et al. High-dose daptomycin for treatment of complicated gram-positive infections: a large, multicenter, retrospective study. Pharmacotherapy 2011; 31: 527-36. (Among 250 US patients who received daptomycin [> 8 mg/kg/day] for complicated infections, 16 [6%] had CK elevations above 100 U/L, but all were asymptomatic; no mention of ALT elevations or hepatotoxicity). 21923436
Gonzalez-Ruiz A, Beiras-Fernandez A, Lehmkuhl H, Seaton RA, Loeffler J, Chaves RL. Clinical experience with daptomycin in Europe: the first 2.5 years. J Antimicrob Chemother 2011; 66: 912-9. (Among 1127 patients treated with daptomycin for various infections [average 10 days], CK elevations arose in 26%, but were usually mild, transient and asymptomatic, being symptomatic and requiring discontinuation in only one patient who had pre-existing renal insufficiency). 21393205
Byren I, Rege S, Campanaro E, Yankelev S, Anastasiou D, Kuropatkin G, Evans R. Randomized controlled trial of the safety and efficacy of Daptomycin versus standard-of-care therapy for management of patients with osteomyelitis associated with prosthetic devices undergoing two-stage revision arthroplasty. Antimicrob Agents Chemother 2012; 56: 5626-32. (Among 49 patients treated with daptomycin for 6 weeks for osteomyelitis, 2 [4%] developed rhabdomyolysis and 4 [8%] discontinued therapy early because of CK elevations). 22908174
Lai CC, Sheng WH, Wang JT, Liao CH, Ho MW, Chen CJ, Chen DL, et al. Safety and efficacy of daptomycin for the treatment of hospitalized adult patients in Taiwan with severe staphylococcal infections. J Microbiol Immunol Infect 2012; 45: 52-7. (Among 52 Taiwanese adults treated with daptomycin, CK elevations occurred in 5 [10%] and ALT elevations in 2 [4%], but most were mild). 22153759
Kwon H, Lee SH, Kim SE, Lee JH, Jee YK, Kang HR, Park BJ, et al. Spontaneously reported hepatic adverse drug events in Korea: multicenter study. J Korean Med Sci 2012; 27: 268-73. (Summary of 2 years of adverse event reporting in Korea; of 9360 reports, 567 were liver related, but none were attributed to daptomycin). 22379337
Colomba C, Rubino R, Siracusa L, Mazzola G, Titone L. Rhabdomyolysis associated with the co-administration of daptomycin and pegylated interferon α-2b and ribavirin in a patient with hepatitis C. J Antimicrob Chemother 2012; 67: 249-50. (Patient with chronic hepatitis C receiving peginterferon and ribavirin, was receiving antibiotics for a gluteal absess and developed muscle aches and fever after a second dose of daptomycin [CPK 12933 U/L rising to 45257 U/L, ALT 371 U/L, ALT 67 U/L, Alk P and bilirubin not given], resolving wihtin 10 days of stopping daptomycin). 21965434
Kullar R, Casapao AM, Davis SL, Levine DP, Zhao JJ, Crank CW, Segreti J, et al. A multicentre evaluation of the effectiveness and safety of high-dose daptomycin for the treatment of infective endocarditis. J Antimicrob Chemother 2013; 68: 2921-6. (Among 70 adults treated with daptomycin for endocarditis, none developed a serious adverse event attributable to the antibiotic). 23928022
Bookstaver PB, Bland CM, Qureshi ZP, Faulkner-Fennell CM, Sheldon MA, Caulder CR, Hartis C; SERGE-45 Investigators. Safety and effectiveness of daptomycin across a hospitalized obese population: results of a multicenter investigation in the southeastern United States. Pharmacotherapy 2013; 33: 1322-30. (Among 126 obese patients treated with daptomycin for an average of 20 days, adverse events included CK elevations [>500 U/L] in 14% of patients; no mention of ALT elevations or hepatotoxicity). 23712701
Casapao AM, Kullar R, Davis SL, Levine DP, Zhao JJ, Potoski BA, Goff DA, et al. Multicenter study of high-dose daptomycin for treatment of enterococcal infections. Antimicrob Agents Chemother 2013; 57: 4190-6. (Among 245 patients with enterococcal infections treated with high doses of daptomycin, 7 [3%] had CK elevations, but none were above 10 times ULN and all were asymptomatic; no mention of hepatotoxicity or ALT elevations). 23774437
Rege S, Mohr J, Lamp KC, Yoon M, Lindfield KC. Safety of daptomycin in patients completing more than 14 days of therapy: results from the Cubicin® Outcomes Registry and experience. Int J Antimicrob Agents 2013; 41: 421-5. (Safety analysis in 2263 patients given daptomycin for more than 14 days found only 3 patients with CK elevations and rare instances of nausea and rash; ALT elevations and hepatotoxicity not mentioned). 23394685
Lai CC, Sheng WH, Wang JT, Cheng A, Chuang YC, Chen YC, Chang SC. Safety and efficacy of high-dose daptomycin as salvage therapy for severe gram-positive bacterial sepsis in hospitalized adult patients. BMC Infect Dis 2013; 13: 66. (Among 67 patients with severe infections treated with daptomycin, bone marrow suppression occurred in 70%, abnormal ALT levels in 29% and renal dysfunction in 20% of patients, but the abnormalities were usually due to the underlying illness rather than the antibiotic therapy). 23379510
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to daptomycin). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9 (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, but none were attributed to daptomycin). 24552865
Bohm N, Makowski C, Machado M, Davie A, Seabrook N, Wheless L, Bevill B, et al. Case report and cohort analysis of drug-induced liver injury associated with daptomycin. Antimicrob Agents Chemother 2014; 58: 4902-3. (31 year old man with bacterial endocarditis due to MRSA, developing worsening liver tests within 5 days of starting daptomycin [bilirubin 0.6 rising to 1.8 mg/dL, ALT ~250 to 800 U/L, Alk P ~100 to 400 U/L], improving once daptomycin was stopped). 24820087
King ST, Walker ED, Cannon CG, Finley RW. Daptomycin-induced rhabdomyolysis and acute liver injury. Scand J Infect Dis 2014; 46: 537-40. (44 year old African American women with osteomyelitis developed rhabdomyolysis a few days after starting daptomycin and ciprofloxacin [bilirubin normal, ALT 236 U/L, AST 750 U/L, Alk P 207 U/L, CPK 16710 U/L, creatinine 4.7 mg/dL], resolving within 1-2 months of stopping daptomycin). 24801642
Bland CM, Bookstaver PB, Lu ZK, Dunn BL, Rumley KF; Southeastern Research Group Endeavor (SERGE-45). Musculoskeletal safety outcomes of patients receiving daptomycin with HMG-CoA reductase inhibitors. Antimicrob Agents Chemother 2014; 58: 5726-31. (Among 220 patients treated with daptomycin, the 49 who were also receiving statins were more likely to have mucle pains [6% vs 3%] and DPK elevations above 1000 U/L [10% vs 5%] than those who were not, but the differences were not statistically significant). 25022580
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 2 were attributed to daptomycin). 25754159
Mo Y, Nehring F, Jung AH, Housman ST. Possible hepatotoxicity associated with daptomycin: a case report and literature review. J Pharm Pract 2016; 29: 253-6. (49 year old woman with multiple medical problems developed jaundice while being treated for a MRSA infection with daptomycin in a dose of 300 mg intravenously once daily for 3 weeks [bilirubin 5.8 mg/dL, ALT 1449 U/L, Alk P 935 U/L, INR 4.15, CPK 45 U/L], with slow and incomplete recovery after stopping daptomycin). 26763341

## OTHER REFERENCE LINKS

1. Recent References on Daptomycin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(zileuton/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Daptomycin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=zileuton)